# Imipramine

## OVERVIEW

### Introduction

Imipramine is a tricyclic antidepressant that continues to be widely used in the therapy of depression. Imipramine can cause mild and transient serum enzyme elevations and is rare cause of clinically apparent acute cholestatic liver injury.

### Background

Imipramine (im ip' ra meen) is a dibenzazepine derived tricyclic antidepressant which acts by inhibition of serotonin and norepinephrine reuptake within synaptic clefts in the central nervous system, thus increasing brain levels of these neurotransmitters. Imipramine is indicated for therapy of depression and was approved for this indication in the United States in 1959; it is still widely used, with more than 1 million prescriptions being filled yearly. Imipramine is also used for childhood enuresis. Imipramine is available in generic forms and under the brand names of Tofranil in 10, 25, and 50 mg tablets and as capsules of 75, 100, 125 and 150 mg for nighttime dosing. The typical recommended dose for depression in adults is 75 to 100 mg daily in divided doses, increasing gradually to a maximum of 200 mg daily. Imipramine can also be given as a single nighttime dose. The recommended dose in children (ages 6 years or above) is 25 to 75 mg daily 1 hour before bedtime. Common side effects include dizziness, headache, drowsiness, restlessness, confusion, gastrointestinal upset, increased appetite, weight gain, blurred vision, dry mouth and urinary retention.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in up to 20% of patients on long term therapy with imipramine, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually mild, asymptomatic and transient, reversing even with continuation of medication. Rare instances of clinically apparent acute liver injury as well as prolonged jaundice have been reported due to imipramine. The onset of jaundice is usually with 1 to 8 weeks of starting therapy. The pattern of enzyme elevations varies from hepatocellular to mixed or cholestatic. Signs and symptoms of hypersensitivity (fever, rash, eosinophilia) are common, but usually not very prominent. Rapid recurrence with rechallenge is common. Autoantibody formation is rare. Rare instances of acute liver failure and death attributed to imipramine have been reported.

Likelihood score: B (likely rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which imipramine causes serum aminotransferase elevation is not known. It undergoes extensive hepatic metabolism and a possible cause of liver injury is production of an intermediate of metabolism that triggers a hypersensitivity reaction.

### Outcome and Management

The serum aminotransferase elevations that occur on imipramine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. The acute hepatitis caused by imipramine is typically self-limited and benign, but can be severe and even fatal. Instances of prolonged jaundice compatible with vanishing bile duct syndrome have been reported. Rechallenge with imipramine usually causes a prompt recurrence of the liver injury and should be avoided. While cross reactivity of hepatic injury with other tricyclic antidepressants has rarely been described, switching to another form of antidepressants such as the selective serotonin reuptake inhibitors is more prudent and is likely to be safe.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, Tricyclics: Amitriptyline, Amoxapine, Clomipramine, Desipramine, Doxepin, Nortriptyline, Protriptyline, Trimipramine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Imipramine – Tofranil®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=imipramine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Imipramine | 50-49-7 | C19-H24-N2 | Image of Imipramine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 April 2018

Zimmerman HJ. Tricyclic antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 495-8. (Expert review of hepatotoxicity published in 1999; hepatic injury caused by tricyclic antidepressants is less frequent and less consistent than with monamine oxidase inhibitors).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3nd ed. Amsterdam: Elsevier Inc, 2013, pp. 443-62. (Review of tricylic antidepressant hepatotoxicity published in 2013; imipramine is listed as causing hepatocellular, mixed and cholestatic liver injury at a frequency of 0.5-1% with a latency ranging from 1 week to 1 year).
O'Donnel JM, Shelton RC. Pharmacotherapy of depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 398415. (Textbook of pharmacology and therapeutics; imipramine and amitriptyline inhibit both norepinephrine and serotonin reuptake; modification of the tricyclic structure led to the synthesis of the first SSRIs).
Lund MA. [Jaundice during therapy with imipramine] Ikterus unter behandling med imipramine. Ugeskr Laeg 1962; 124: 800-2. (55 year old man developed jaundice 3 weeks after starting imipramine [bilirubin ~11 mg/dL, near normal ALT, Alk P 450 U/L], resolving within 2 months documented by 3 liver biopsies). 14467350
Miller M. Neuropathy, agranulocytosis and hepatotoxicity following imipramine therapy. Am J Psychiatry 1963; 20: 185-6. Not in PubMed (66 year old woman developed nausea 8 days after stopping a 19 day course of imipramine [no bilirubin levels given, AST 115 U/L, Alk P 2.5 times ULN], with subsequent neutropenia and neuropathy while liver test elevations resolved within 2 weeks of stopping).
Hoaken PSC. Jaundice during imipramine treatment. Can Med Assoc J 1964; 90: 1367. (44 year old woman developed fever, fatigue and jaundice 20 days after starting imipramine [bilirubin 5.0 mg/dL, Alk P twice ULN], resolving clinically within 2 weeks of stopping). 14156834
Strothers G. Jaundice and its relation to therapeutic agents. Lancet 1965; 1: 434. (62 year old woman developed jaundice 50 days after starting chlordiazepoxide and imipramine [bilirubin 11.9 mg/dL, ALT 230 U/L, Alk P ~8 times ULN]; authors attributed case to imipramine and not the benzodiazepine). 14238106
Klerman GL, Cole JO. Clinical pharmacology of imipramine and related antidepressant compounds. Pharmacol Rev 1965; 17: 101-41. (Extensive review of structure, pharmacology, clinical effects, mechanisms of action, drug interactions, and side effects of tricyclic antidepressants; jaundice is reported to occur in 0.5 to 1% of subjects, but usually resolves rapidly with stopping). 14294030
Kramp JL. Glutamic pyruvic acid transaminases during treatment with amitriptyline and imipramine. Acta Psychiatr Scand 1967; 43: 1-7. (ALT levels were elevated in 4 of 149 patients treated with amitriptyline or imipramine, but the peak value was only 100 U/L). 6059707
Powell WJ, Koch-Weser J, Williams RA. Lethal hepatic necrosis after therapy with imipramine and desipramine. JAMA 1968; 206: 642-5. (80 year old woman developed rash 2 weeks after starting imipramine and was switched to desipramine for 3 days when she developed jaundice, fever and desquamating rash [bilirubin 7.8 rising to 27 mg/dL, AST 330 U/L, Alk P 4 times ULN, atypical lymphocytes 6%], subsequently suffering hepatic coma, infections, hypotension and death). 4234079
Short MH, Burns JM, Harris ME. Cholestatic jaundice during imipramine therapy. JAMA 1968; 206: 1791-2. (73 year old woman developed jaundice, fever and confusion 3 weeks after starting imipramine [bilirubin 5.9 mg/dL, Alk P 2.5 times ULN], with liver biopsy showing intrahepatic cholestasis and rapid improvement upon stopping). 5754834
Karkalas Y, Lal H. Jaundice following therapy with imipramine and cyproheptadine. Clin Toxicol 1971; 4: 47-53. (59 year old man developed jaundice 38 days after starting imipramine [and periactin for pruritus] [bilirubin 3.0 mg/dL, ALT 1100 U/L, Alk P 3 times baseline level], resolving within 3 weeks of stopping). 5097484
Clarke AE, Maritz VM, Denborough MA. Phenothiazines and jaundice. Aust N Z J Med 1972; 2: 376-82. (Chlorpromazine and amitriptyline cause precipitation of proteins when added to human bile in vitro and hepatotoxicity of these agents may relate to this characteristic). 4144624
Weaver GA, Pavlinac D, Davis JS. Hepatic sensitivity to imipramine. Am J Dig Dis 1977; 22: 551-3. (40 year old woman was found to have elevations in Alk P [450 U/L] and eosinophilia [9%] when admitted for depression, 2 months after starting imipramine, improved on stopping and increased again after single dose rechallenge; liver biopsy showing mild nonspecific changes). 868834
Fiori MG. Tricyclic antidepressants: a review of their toxicology. Curr Dev Psychopharmacol 1977; 4: 71-110. (Review of cardiac, hepatic, neurological, fetal and psychotoxicity of tricyclic antidepressants; most cases of hepatotoxicity have been attributed to hypersensitivity, but tricyclics are taken up and extensively metabolized by hepatocytes). 340145
Bui HD, Chaney RH. Transient hepatitis due to low dose neuroleptic medication. Am J Gastroenterol 1989; 84: 578-9. (19 year old developed agitation, tachycardia, fever and leukocytosis 8 days after starting imipramine [bilirubin normal, ALT 286 U/L, Alk P 140 U/L, CPK 11,260 U/L], abnormalities resolving in days with hydration and stopping therapy; neuroleptic malignant syndrome). 2719021
Horst DA, Grace ND, LeCompte PM. Prolonged cholestasis and progressive hepatic fibrosis following imipramine therapy. Gastroenterology 1980; 79: 550-4. (53 year old woman developed rash and fever 7 days after starting imipramine followed by jaundice with eosinophilia [bilirubin 10 mg/dL, AST 115 U/L, Alk P ~4 times ULN], with persistent jaundice and severe pruritus for 1 year, followed by gradual improvement; but 12 year follow up showed minor alkaline phosphatase and AST elevations with normal bilirubin; liver biopsies showed duct absence initially, but returning in follow up, although fibrosis was present). 7429116
Moskovitz R, DeVane CL, Harris R, Stewart RB. Toxic hepatitis and single daily dosage imipramine therapy. J Clin Psychiatry 1982; 43: 165-6. (33 year old woman developed abnormal liver enzymes 4 weeks after starting imipramine [bilirubin 1.1 mg/dL, ALT 1308 U/L, Alk P 364 U/L], resolving rapidly upon stopping). 7068550
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (Among 572 cases of drug induced liver disease seen between 1968-78 in Denmark, psychotropic agents accounted for 93 cases, 54 of which were due to chlorpromazine; tricyclics not specifically mentioned). 6982502
Larrey D, Rueff B, Pessayre D, Algard M, Geneve J, Benhamou JP. Cross hepatotoxicity between tricyclic antidepressants. Gut 1986; 87-90. (39 year old woman developed abdominal pain 2 weeks after starting amineptine [a tricyclic antidepressant] with fever and eosinophilia [bilirubin 1.2 mg/dL, ALT 1360 U/L, Alk P 1.5 times ULN], resolving rapidly on stopping but recurring 7 days after starting clomipramine [ALT 1050 U/L, Alk P 1.5 times ULN], again resolving rapidly upon stopping). 3721296
Geneve J, Larrey D, Pessayre D, Benhamou JP. Structure tricyclique des medicaments et hepatotoxicite. Gastroenterol Clin Biol 1987; 11: 242-9. (Review of structural similarity and hepatotoxicity of tricyclic antidepressants focusing on amineptine, imipramine and amitriptyline). 2884161
Morrow PL, Hardin NJ, Bonadies J. Hypersensitivity myocarditis and hepatitis associated with imipramine and its metabolite, desipramine. J Forensic Sci 1989; 34: 1016-20. (Two patients with complicated medical histories [one on desipramine and one imipramine] died suddenly and were found to have myocarditis on autopsy with liver showing eosinophils and lymphocytes in portal areas; no jaundice or information on ALT levels). 2760582
Schaefer MS, Edmunds RS, Markin RP, Wood RP, Pillen TJ, Shaw BW. Hepatic failure associated with imipramine therapy. Pharmacotherapy 1990; 10: 66-9. (11 year old boy developed jaundice 7 days after starting imipramine for enuresis [bilirubin 15.0 mg/dL, ALT 3260 U/L, Alk P 619 U/L] which worsened despite stopping drug, with progression to liver failure and liver transplantation 8 days after presentation and 3 weeks after starting imipramine). 2315196
Pirmohamed MKL, Kittringham NR, Parkl BK. Idiosyncratic reactions to antidepressants: a review of the possible mechanism and predisposing factors. Pharm Ther 1992; 53: 105-25. (Review of idiosyncratic reactions to antidepressants; possible mechanism of injury being production of a chemically reactive metabolite that is either directly toxic or induces a hypersensitivity reaction). 1641399
Berson A, Fréneaux E, Larrey D, Lepage V, Douay C, Mallet C. Possible role of HLA in hepatotoxicity. An exploratory study. J Hepatol 1994; 20: 336-42. (Human leukocyte antigen [HLA] haplotypes done on 71 patients with drug induced liver disease; among 12 due to tricyclics [7 amineptine, 3 amitriptyline, 2 clomipramine], 6 [50%] had HLA A11 including 2 of the 3 amitriptyline cases; 12% of controls had this allele). 8014443
Remy AL, Larrey D, Pageaux GP, Desprez D, Ramos J, Michel H. Cross hepatotoxicity between tricyclic antidpressants and phenothiazines. Eur J Gastroenterol 1995; 7: 373-6. (65 year old woman developed fatigue and serum enzyme elevations [ALT ~1300 U/L; Alk P ~380 U/L] 1 month after starting trimipramine; 3 years later she developed nausea and ALT elevations 10 days after starting desipramine [ALT ~250 U/L], and 2 years later developed abdominal pain and fever and enzyme elevations [ALT ~1100 U/L, Alk P ~ 510 U/L] 8 days after starting cyamemazine; each time with rapid recovery and no jaundice). 7600146
Ilan Y, Samuel D, Teynes M, Tur-Kaspa R. Hepatitis failure associated with imipramine therapy. Pharmacopsychiatry 1996; 29: 79-80. (48 year old man developed jaundice 4 months after starting imipramine [bilirubin 30.4 mg/dL, ALT 3998 U/L, Alk P 250 U/L], progressing to hepatic failure but spontaneous recovery within 3 months of stopping). 8741026
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry 1999; 156: 1686-96. (Systematic review of 81 articles on weight change with antipsychotics; using change after 10 weeks to compare: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kilograms). 10553730
Grohmann R, Rüther E, Engel RR, Hippius H. Assessment of adverse drug reactions in psychiatric inpatients with the AMSP drug safety program: methods and first results for tricyclic antidepressants and SSRIs. Pharmacopsychiatry 1999; 32: 21-8. (Analysis of reporting of adverse events among inpatients in 29 German hospitals between 1993 to 1997; 896 severe adverse events among 48,564 patients [1.8%], both total and hepatic events were more common with tricyclics than SSRIs). 10071179
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI.Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry 2002; 63: 135-7. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999 identified 99 cases; among SSRIs, 26 were due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone with 29/100,000). 11874214
Lucena M, Carvajal A, Andrade R, Velasco A. Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf 2003; 2: 249-62. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; tricyclics are less likely to cause injury than MAO inhibitors; predominantly cholestatic patterns of liver injury with onset in first 2-3 weeks; occasional reports of prolonged cholestasis). 12904104
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry 2004; 37 Suppl 1: S39-45. (53,042 patients treated with antidepressants in 35 psychiatric hospitals in Germany from 1993-2000 were monitored for adverse drug reactions; increased liver enzymes reported in 16% on tricyclics, 5.5% on SSRIs and 12% of monamine oxidase inhibitors). 15052513
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were due to amitriptyline with a relative risk of 14.2: estimated frequency of 6 per 100,000 person-year exposures). 17539979
DeSanty KP, Amabile CM. Antidepressant-induced liver injury. Ann Pharmacother 2007; 41: 1201-11. (Review of drug induced liver injury and summary analysis of reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents). 17609231
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 1 case was attributed to amitriptyline, but no other tricyclic was mentioned). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to tricyclic antidepressants). 20949552
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to amitriptyline, but no other tricyclic antidepressant was listed). 21788760
Park SH, Ishino R. Liver injury associated with antidepressants. Curr Drug Saf 2013; 8: 207-23. (Review of antidepressant induced liver injury). 23914755
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to imipramine or other tricyclic antidepressant). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one was attributed to amitriptyline but none to imipramine or other tricyclic antidepressants). 24552865
Voican CS, Corruble E, Naveau S, Perlemuter G. Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry 2014; 171: 404-15. (Review of hepatotoxicity of antidepressants, mentions cases of cholestatic jaundice and vanishing bile duct syndrome, but that hepatocellular injury can also occur due to imipramine). 24362450
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants only one of which was due to a tricylic, imipramine: a 33 year old woman developed jaundice with a mixed enzyme pattern 1 month after starting imipramine which resolved within a month of stopping).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol 2016; 19. pii: pyv126. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26721950) (Among 184,234 psychiatric inpatients from 80 European hospitals, 149 cases [0.08%] of drug induced liver injury were reported, of whom 18 [13%] were taking trimipramine, although none were receiving imipramine]).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al.; DILI-IT Study Group. Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf 2018; 41: 95-102. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28770534) (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an prospective study between 2010 and 2014, 17 had been exposed to antidepressants including only 1 who received a tricyclic [amitriptyline]).

## OTHER REFERENCE LINKS

1. Recent References on Imipramine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(imipramine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Imipramine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=imipramine)